# Cemiplimab

## OVERVIEW

### Introduction

Cemiplimab is a human monoclonal antibody to the programmed cell death receptor 1 (PD-1) and a checkpoint inhibitor that is used in the immunotherapy of advanced and metastatic cancer. Cemiplimab therapy has many adverse events and particularly immune related conditions including acute hepatocellular and cholestatic liver injury which can be serious and even life threatening.

### Background

Cemiplimab (ce mip' li mab) is a human recombinant monoclonal IgG4 antibody to the programmed cell death receptor 1 (PD-1), which has distinctive immunomodulatory activity and is used in cancer immunotherapy. PD-1 is an important checkpoint molecule that is expressed on activated T and B cells and macrophages. Engagement of the PD-1 receptor modulates and down regulates T cell responses. Binding of the monoclonal antibody to the PD-1 receptor prevents ligand attachment and activation of the programmed cell death pathways, thereby allowing for a continued activation and proliferation of T cells. The subsequent enhancement of cytotoxic reactivity may play a beneficial role in cancer immunotherapy by breaking immunological tolerance to cancer cell neo-antigens. In prelicensure clinical studies, cemiplimab therapy resulted in objective responses in patients with advanced, metastatic cutaneous squamous cell carcinoma, and a proportion of patients had a long term remission. Cemiplimab was approved for use in cutaneous squamous cell carcinoma in the United States in 2018 and indications were subsequently expanded to include advanced or metastatic, refractory basal cell carcinoma and non-small cell lung cancer (NSCLC). It is under evaluation in several other forms of cancer, including renal, ovarian and uterine carcinoma, lymphomas and multiple myeloma. Cemiplimab is available in solution in single use vials of 350 mg in 7 mL (50 mg/mL) under the brand name Libtayo. The recommended dose in adults is 350 mg given intravenously over 30 minutes every 3 weeks.

As with most checkpoint inhibitors, side effects of cemiplimab are common and can include fatigue, headache, musculosketetal pain, arthralgia, abdominal pain, diarrhea, nausea, vomiting, decreased appetite, weight loss, fever, cough, dyspnea, pruritus, and rash. Importantly, as a result of the immune enhancement, between 15% and 25% of treated patients develop immune related side effects. These reactions are high grade in 10% of patients and can include enterocolitis, dermatitis, endocrinopathy, pneumonitis, neuropathy, nephritis and hepatitis. Most of these reactions respond to drug discontinuation and immunosuppressive therapy, but some have resulted in fatalities and some have required permanent discontinuation of the checkpoint inhibitor and long term immunosuppressive therapy. Baseline screening and regular monitoring for these adverse events during cemiplimab therapy is recommended. Early recognition and prompt management of side effects is an integral component of proper use of checkpoint inhibitors. Checkpoint inhibitors should be used only by health care professionals with training in immunotherapy and experience in the management of the side effects of immunomodulatory agents. Other rare but potentially severe adverse effects of cemiplimab include infusion reactions and embryo-fetal toxicity.

### Hepatotoxicity

Mild-to-moderate serum aminotransferase elevations are common (10% to 20%) during cemiplimab therapy but are usually self-limited and resolve even with continuing cyclic therapy. Serum ALT elevations above 5 times the upper limit of normal (ULN) occur in 1% to 4% of patients, and a proportion of these individuals develop clinically apparent immune related liver injury that can be severe. Typically, onset of immune mediated liver injury arises after 2 to 6 cycles of checkpoint inhibitor therapy. The pattern of enzyme elevation is usually hepatocellular but may be mixed or even cholestatic. Monitoring of serum enzymes is recommended with dose interruption for values above 3 times the ULN and discontinuation for values above 8 times the ULN. When serum aminotransferase levels remain elevated despite discontinuation or with development of symptoms or jaundice, early intervention with immunosuppressive therapy is prudent and generally results in rapid resolution. Liver histology usually demonstrates an acute hepatitis-like pattern with focal or confluent necrosis and prominent lymphocytic infiltrates of activated T cells, which is compatible with an immune mediated hepatic injury. Autoantibodies are usually not present and immunoglobulin levels may not be elevated. Restarting monoclonal antibody therapy can result in recurrence of injury. Immune mediated hepatitis appears to be more frequent with anti-CTLA-4 than with anti-PD-1 or anti-PD-L1 checkpoint inhibitors. Among 810 patients treated with cemiplimab in prelicensure studies, 16 (2%) developed an immune related hepatitis, all of whom required corticosteroid therapy and that was fatal in 1 (0.2%).

A proportion of patients receiving checkpoint inhibitors develop cholestatic rather than hepatocellular liver injury. Cholestatic forms of immune mediated liver injury generally arise later than the hepatocellular forms (after 3 to 10 cycles) and are often accompanied by abdominal pain and jaundice. Alkaline phosphatase levels are markedly elevated while aminotransferase levels are only modestly increased. Imaging studies may show irregular dilatation of the intra- and/or extra-hepatic bile ducts and thickening of the gall bladder and bile duct wall, but without evidence of frank obstruction. Liver biopsy shows portal inflammation and bile duct injury and endoscopic biopsy of the bile duct epithelium shows inflammation and scarring. The general features suggest a secondary form of sclerosing cholangitis referred to as checkpoint inhibitor cholangiopathy. Therapy with immunosuppression may improve alkaline phosphatase and bilirubin levels but rarely leads to complete recovery, and long term cholestasis and hepatic failure can occur. Some patients with a cholestatic form of immune related hepatitis do not manifest the large bile duct changes but demonstrate loss and paucity of the smaller, intrahepatic portal bile ducts resulting in a vanishing bile duct syndrome similar to primary biliary cholangitis (PBC).

The effects of PD-1 inhibition on chronic hepatitis B are not well defined but convincing examples of reactivation of hepatitis B have been described due to other checkpoint inhibitors. Most cases have occurred in patients with preexisting HBsAg, but rare instances were reported in individuals suspected of having with anti-HBc without HBsAg. Thus, screening patients for HBsAg, anti-HBc and anti-HBs is appropriate before initiating immunotherapy with checkpoint inhibitors. Patients with HBsAg should be considered for prophylaxis with an antiviral agent with potent activity against HBV such as entecavir or tenofovir. In patients with anti-HBc without HBsAg, monitoring and close attention to liver test abnormalities is probably adequate if antiviral therapy can be introduced rapidly for early evidence of reactivation. There has not been adequate experience with cemiplimab in regard to the risk of reactivation of hepatitis B to provide rates of reactivation with and without antiviral prophylaxis.

Likelihood score: C (probable cause of clinically apparent liver injury and possible cause of reactivation of hepatitis B).

### Mechanism of Injury

The mechanism of liver injury due to cemiplimab is likely to be immunologically mediated, and many cases of checkpoint related, immune mediated hepatitis have appeared to respond to corticosteroid or immunosuppressive therapy. Liver biopsies in cases of hepatocellular injury and bile duct epithelial cell biopsies in cases with cholangiopathic injury demonstrate necrosis and inflammatory cell infiltration with cytotoxic CD8+ T cells, suggesting that the checkpoint inhibition allowed for activation of T cells directed at hepatocyte or cholangiocyte cell surface antigens.

### Outcome and Management

Guidelines for management of patients receiving cemiplimab recommend monitoring of liver tests and interrupting therapy for patients who develop serum aminotransferase elevations above 3 times the ULN and discontinuing treatment for values above 8 times the ULN. Corticosteroid therapy can be considered for patients with persistent ALT elevations or if symptoms or jaundice arise, initiating therapy with high dose intravenous methylprednisolone and switching to oral prednisone after 1 to 2 days, continuing tapering doses for at least 30 days.

Most cases of hepatitis due to checkpoint inhibitors resolve with prompt institution of immunosuppressive therapy which can be withdrawn within 1 to 3 months. In some cases, adding a second agent (such as mycophenolate mofetil, azathioprine, antithymocyte globulin, or tacrolimus) may be necessary. The few fatal cases that have been reported during immunotherapy with checkpoint inhibitors occurred in patients who had other severe immune related adverse events (Stevens Johnson syndrome, capillary leak syndrome), or had refractory cholestatic liver injury, or had a delay in starting corticosteroid therapy. Patients with immune related adverse events due to cemiplimab can restart therapy once the adverse event has resolved, although concurrent immunosuppressive therapy may be necessary. Switching to another type of checkpoint inhibitor (anti-CTLA-4 or anti-PD-L1) is likely to be better tolerated.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies, Checkpoint Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cemiplimab – Libtayo®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Cemiplimab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Cemiplimab | 1801342-60-8 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 23 June 2022

Abbreviations used: CPI, checkpoint inhibitor; CTLA-4, cytotoxic T lymphocyte associated antigen 4; HCC, hepatocellular carcinoma; irAE, immune related adverse event; PD-1, programmed cell death receptor 1; PD-L1, programmed cell death receptor ligand-1; NSCLC, non-small cell lung cancer; SCLC, small cell lung cancer.

Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Danan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2018/761097Orig1s000MultidisciplineR.pdf (FDA Clinical Review of safety and efficacy of cemiplimab with specific discussion of immune mediated hepatitis: pages 118-9).
Kleiner DE, Berman D. (2012). Pathologic changes in ipilimumab-related hepatitis in patients with metastatic melanoma. Dig Dis Sci. (Clinical and histological features of 5 patients with acute liver injury due to ipilimumab; 3 men and 2 women, ages 43 to 76 years, arising after 2-4 courses, 39-71 days after initial dose [peak bilirubin 1.5-5.1 mg/dL, ALT 326-3070 U/L, Alk P 206-427 U/L], only one had autoantibodies, resolving with immunosuppressive therapy within 1-4 months; one had recurrence on rechallenge; liver biopsies showed acute hepatitis, usually with prominent inflammation, interface hepatitis and confluent necrosis: Case 1 Ipilimumab).
Teply BA, Lipson EJ. (2014). Identification and management of toxicities from immune checkpoint-blocking drugs. Oncology (Williston Park). (Clinical review of the toxicities of immune checkpoint blocking drugs such as ipilimumab, pembrolizumab and nivolumab; mentions that elevations of serum aminotransferase elevations should lead to careful exclusion of other causes of liver injury and increased monitoring; that elevations above 3 times ULN should lead to withholding the drug and starting corticosteroids; that elevations above 5 times ULN should lead to hospital admission and immediate administration of high doses of corticosteroids).
Tumeh PC, Harview CL, Yearley JH, Shintaku IP, Taylor EJ, Robert L, Chmielowski B, et al. (2014). PD-1 blockade induces responses by inhibiting adaptive immune resistance. Nature. (Analysis of expression of PD-1 and its ligand on CD8+ T cells at the margins of melanoma tumors before and after treatment with pembrolizumab showed that responders to therapy typically had high levels of expression of PD-1 and its ligand).
Sharma P, Allison JP. (2015). The future of immune checkpoint therapy. Science. (Commentary and review of the rationale, history, clinical efficacy and mechanism of action of immune checkpoint therapy).
Abdel-Rahman O, El Halawani H, Fouad M. (2015). Risk of elevated transaminases in cancer patients treated with immune checkpoint inhibitors: a meta-analysis. Expert Opin Drug Saf. (Analysis of publications on checkpoint inhibitors indicate that therapy is associated with high rates of ALT elevations).
Markham A, Duggan S. (2018). Cemiplimab: first global approval. Drugs. (Review of the history of development, mechanism of action, pharmacology, clinical efficacy and safety of cemiplimab; mentions that immune mediated hepatitis occurred in 2.1% of 534 treated subjects).
Migden MR, Rischin D, Schmults CD, Guminski A, Hauschild A, Lewis KD, Chung CH, et al. (2018). PD-1 blockade with cemiplimab in advanced cutaneous squamous-cell carcinoma. N Engl J Med. (Among 59 patients with metastatic cutaneous squamous cell carcinoma treated with cemiplimab the objective response rate was 47% and common adverse events were diarrhea [27%], fatigue [24%], nausea [17%], constipation [15%] and rash [15%]; elevations in ALT levels occurred in 8% of subjects, but were less than 5 times ULN in all).
Ruggiero R, Fraenza F, Scavone C, di Mauro G, Piscitelli R, Mascolo A, Ferrajolo C, et al. (2020). Immune checkpoint inhibitors and immune-related adverse drug reactions: data from Italian Pharmacovigilance Database. Front Pharmacol. (Among 2088 safety reports of checkpoint inhibitors enrolled in an Italian pharmacovigilance registry, 801 were immune related including gastrointestinal [33%], skin [17%] and liver [2.7%] due to nivolumab [70%], pembrolizumab [11%], ipilimumab [15%], atezolizumab [4%] and avelumab [<1%]).
Migden MR, Khushalani NI, Chang ALS, Lewis KD, Schmults CD, Hernandez-Aya L, Meier F, et al. (2020). Cemiplimab in locally advanced cutaneous squamous cell carcinoma: results from an open-label, phase 2, single-arm trial. Lancet Oncol. (Among 78 patients with advanced cutaneous squamous cell carcinoma treated for a median of 9.1 months, the objective response rate was 44% and adverse events included fatigue [42%], diarrhea [27%], pruritus [27%], nausea [21%], rash [13%] and AST elevations [6%], with 1 case of autoimmune hepatitis).
Rischin D, Migden MR, Lim AM, Schmults CD, Khushalani NI, Hughes BGM, Schadendorf D, et al. (2020). Phase 2 study of cemiplimab in patients with metastatic cutaneous squamous cell carcinoma: primary analysis of fixed-dosing, long-term outcome of weight-based dosing. J Immunother Cancer. (Among 115 patients with metastatic cutaneous squamous cell carcinoma treated with cemiplimab objective responses occurred in 45%, and 98% of subjects had adverse events including fatigue, diarrhea, nausea and rash; ALT elevations occurred in 5 patients [4.3%] but none were above 5 times ULN).
Stratigos AJ, Sekulic A, Peris K, Bechter O, Prey S, Kaatz M, Lewis KD, et al. (2021). Cemiplimab in locally advanced basal cell carcinoma after hedgehog inhibitor therapy: an open-label, multi-centre, single-arm, phase 2 trial. Lancet Oncol. (Among 84 patients with advanced and refractory basal cell carcinoma treated with cemiplimab in 38 international centers, the overall objective response rate was 31% and adverse events included hypothyroidism in 8, colitis in 4, adrenal insufficiency in 3, and immune mediated hepatitis in 1).
Hober C, Fredeau L, Pham-Ledard A, Boubaya M, Herms F, Celerier P, Aubin F, et al. (2021). Cemiplimab for locally advanced and metastatic cutaneous squamous-cell carcinomas: real-life experience from the French CAREPI Study Group. Cancers (Basel). (Among 245 patients with advanced or metastatic cutaneous squamous cell carcinoma treated with cemiplimab in 58 French referral centers, the best overall response rate was 50% and severe treatment adverse events arose in 9%, 5 patients [2%] with liver immune events, one case of DRESS and one death due to toxic epidermal necrolysis).
Baggi A, Quaglino P, Rubatto M, Depenni R, Guida M, Ascierto PA, Trojaniello C, et al. (2021). Real world data of cemiplimab in locally advanced and metastatic cutaneous squamous cell carcinoma. Eur J Cancer. (Among 131 patients with cutaneous squamous cell carcinoma treated with cemiplimab in 17 Italian referral centers in 2019 and 2020, the overall response rate was 58% and adverse event rate was 43%; no mention of immune mediated hepatic injury).
Wong GL, Wong VW, Hui VW, Yip TC, Tse YK, Liang LY, Lui RN, et al. (2021). Hepatitis flare during immunotherapy in patients with current or past hepatitis B virus infection. Am J Gastroenterol. (Among 990 patients in Hong Kong with advanced malignancies treated with checkpoint inhibitors between 2014 and 2019 [397 HBsAg positive, 482 with anti-HBc or anti-HBs, 111 negative for both at baseline], 39% of HBsAg-positive vs 30% of HBsAg-negative patients developed ALT elevations during therapy, but only two cases [both HBsAg positive and on prophylaxis] were due to HBV reactivation).
Mustafayev K, Torres H. Hepatitis B virus and hepatitis C virus reactivation in cancer patients receiving novel anticancer therapies. Clin Microbiol Infect. 2022:S1198-743X(22)00119-7. (Review of the literature on reactivation of HBV and HCV in patients on “novel” anticancer therapy concludes that reactivation can occur with checkpoint inhibitor therapy, but largely among HBsAg positive patients and only rarely in patients with resolved hepatitis B).
Yoo S, Lee D, Shim JH, Kim KM, Lim YS, Lee HC, Yoo C, et al. (2022). Risk of hepatitis B virus reactivation in patients treated with immunotherapy for anti-cancer treatment. Clin Gastroenterol Hepatol. (Among 3,465 patients with advanced malignancies treated with checkpoint inhibitors between 2015 and 2020 at a single referral center in Korean, 511 [15%] were HBsAg positive at baseline, reactivation of HBV occurred in 5 of 511 [1%] HBsAg positive vs none of 2,954 HBsAg negative patients, arising in 2 of 464 [0.4%] patients given prophylaxis [both having stopped antivirals] vs 3 of 47 not given prophylaxis [6.4%]; reactivation arising after 3-141 weeks [median 54 weeks] of nivolumab [n=2], pembrolizumab [n=2] or ipilimumab and nivolumab [n=1] treatment, ALT peak 53 to 1768 IU/mL, HBV DNA 6,100 to 3.9 million IU/mL, resolving with 2 to 6 weeks of starting antiviral therapy).
Tewari KS, Monk BJ, Vergote I, Miller A, de Melo AC, Kim HS, Kim YM, et al. (2022). Investigators for GOG Protocol 3016 and ENGOT Protocol En-Cx9. Survival with cemiplimab in recurrent cervical cancer. N Engl J Med. (Among 608 women with refractory cervical cancer treated with cemiplimab or chemotherapy, the median overall survival was 12 vs 8.5 months and ALT elevations arose in 4.3% with cemiplimab vs 6.9% with conventional chemotherapy, ALT values above 5 times ULN in 0.7% in both groups, while immune mediated hepatitis arose in 4 cemiplimab-treated [1.3%] but no control patients).
Marron TU, Fiel MI, Hamon P, Fiaschi N, Kim E, Ward SC, Zhao Z, et al. (2022). Neoadjuvant cemiplimab for resectable hepatocellular carcinoma: a single-arm, open-label, phase 2 trial. Lancet Gastroenterol Hepatol. (Among 21 patients with resectable hepatocellular carcinoma treated with 8 cycles of adjuvant cemiplimab [every 3 weeks] before resection, 4 had significant tumor necrosis while 3 had a partial response and there were no hepatic adverse events).
Swanson L, Kassab I, Tsung I, Worden FP, Fontana RJ. (2022). Infrequent liver injury from cemiplimab in patients with advanced cutaneous squamous cell carcinoma. Immunotherapy. (Among 39 patients with advanced cutaneous squamous cell carcinoma treated with cemiplimab at a referral medical center between 2018 and 2020, 4 [10%] developed liver injury during therapy, 2 [5%] of which were considered immune mediated: 86 year old woman and 56 year old man developed liver injury 42 and 80 days after starting [after 2 and 5 infusions], with peak bilirubin 0.8 and 1.6 mg/dL, ALT 149 and 28 U/L, Alk P 115 and 509 U/L, both self-limited, one treated with corticosteroids for 6 months and later tolerating re-starting cemiplimab without recurrence).

## OTHER REFERENCE LINKS

1 Recent References on Cemiplimab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Cemiplimab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Cemiplimab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cemiplimab)